# Meclizine

## OVERVIEW

### Introduction

Meclizine is a first generation antihistamine that is used largely to treat vertigo and motion sickness. Meclizine has not been linked to instances of clinically apparent acute liver injury.

### Background

Meclizine (mek' li zeen) is a first generation antihistamine that belongs to the piperazine class of these agents (with cyclizine and hydroxyzine) which are used largely for their antiemetic and sedative effects. Meclizine is used mostly for the treatment of vertigo and symptoms of nausea, vomiting and dizziness associated with motion sickness. Meclizine was first approved for use in the United States in 1957 and is available in tablets and capsules of 12.5, 25 and 50 mg in multiple generic forms and under the trade name Antivert. Meclizine is available in both prescription and nonprescription forms. The recommended adult oral dose for motion sickness is 25 to 50 mg taken one hour before travel. The recommended dose for vertigo is 25 to 100 mg daily in divided doses. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use, meclizine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate to low daily dose and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Meclizine – Generic, Antivert®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Meclizine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Meclizine | 569-65-3 | C25-H27-Cl-N2 | Meclizine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Meclizine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Meclizine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Meclizine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Meclizine)